# Oxcarbazepine

## OVERVIEW

### Introduction

Oxcarbazepine is a keto analogue of carbamazepine and, like the parent drug, is a potent anticonvulsant used alone or in combination with other agents in the therapy of partial seizures. Oxcarbazepine has been linked to rare instances of clinically apparent acute drug induced liver injury which resembles carbamazepine hepatotoxicity.

### Background

Oxcarbazepine (ox" kar baz' e peen) is a keto analog of carbamazepine and functions as a prodrug being rapidly converted to 10-hydroxycarbazepine. Oxcarbazepine and carbamazepine are iminostilbenes related chemically to the tricyclic antidepressants and unrelated in structure to most other anticonvulsants. They appear to act by suppression of spread of seizure activity by reduction in the posttetanic potentiation of synaptic transmission. Oxcarbazepine was approved for use in epilepsy in the United States in 2000 and remains in common use. Oxcarbazepine is indicated for prevention and management of partial, complex, mixed and generalized seizures and is commonly used alone or in combination with other anticonvulsants. It is used off label to treat bipolar disorder. Oxcarbazepine is available as tablets of 150, 300 and 600 mg generically and under the commercial name of Trileptal and as an extended release form under the name Oxtellar XR. Oral formulations for use in children are also available. The recommended starting dose in adults is 300 mg twice daily followed by increases at weekly intervals based upon clinical response, the usual final dose being 600 mg twice daily. Frequent side effects include drowsiness, sedation, ataxia, blurred vision, nausea, vomiting, and skin rash. Uncommon but potentially severe adverse events include hyponatremia, suicidal ideation and behaviors, anaphylaxis and hypersensitivity reactions, serious cutaneous adverse events including Stevens-Johnson syndrome and toxic epidermal necrolysis.

### Hepatotoxicity

Chronic therapy with oxcarbazepine is associated with elevations in serum aminotransferase levels in a small proportion of patients. These elevations are rarely clinically significant and do not usually require dose modification. Clinically apparent hepatotoxicity from oxcarbazepine is uncommon but described, and is less common than occurs with carbamazepine. Oxcarbazepine hepatotoxicity usually arises in the setting of anticonvulsant hypersensitivity syndrome with onset of fever, followed by rash, facial edema, lymphadenopathy, elevations in white count and eosinophilia 2 to 8 weeks after starting therapy. The liver involvement ranges from a mild and transient elevation in serum enzymes to abrupt onset of an acute hepatitis-like syndrome, that can be severe and even fatal. The typical enzyme elevations are usually mixed, but can be either hepatocellular or cholestatic. Liver biopsy shows mixed necroinflammatory-cholestatic injury with prominence of eosinophils and occasionally granulomas.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of oxcarbazepine hepatotoxicity appears to be hypersensitivity or an immunological response to a metabolically generated drug-protein complex. Serious cutaneous reactions due to oxcarbazepine as with carbamazepine has been linked to the HLA-B*15.01 allele, particularly in Han Chinese subjects. Similar HLA-associations have not been linked to liver injury but the numbers of cases described have been few. Oxcarbazepine like other aromatic anticonvulsants may also trigger acute porphyria by inducing delta-aminolevulinic acid (ALA) synthetase activity. It also induces CYP 3A4 and inhibits CYP 2C19 and can cause drug-drug interactions particularly with other drugs used for epilepsy that induce CYP 3A4 such as phenytoin and phenobarbital.

### Outcome and Management

Oxcarbazepine and carbamazepine hepatotoxicity is usually rapidly reversible with stopping therapy, improvements beginning within days. In cases of severe injury, progression to acute liver failure and death can occur. Corticosteroids have been used but with uncertain effectiveness. Cross reactivity with other aromatic anticonvulsants (carbamazepine, phenytoin, phenobarbital, primidone, and lamotrigine) is common, but not invariable. Patients with severe hypersensitivity to oxcarbazepine should avoid exposure to other aromatic anticonvulsants and be switched instead to agents such as a benzodiazepine, valproate, levetiracetam, gabapentin or pregabalin.

Drug Class: Anticonvulsants; see also Carbamazepine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Oxcarbazepine – Generic, Trileptal®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Oxcarbazepine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Oxcarbazepine | 28721-07-5 | C15-H12-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 30 July 2020

See also references for Carbamazepine.

Abbreviations used: DRESS, drug rash with eosinophilia and systemic symptoms; SJS/TEN, Stevens-Johnson syndrome and toxic epidermal necrolysis.
Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; oxcarbazepine is not discussed).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury mentions that oxcarbazepine undergoes less oxidative metabolism than carbamazepine and is a less potent P450 enzyme inducer; cross reactivity between the 2 drugs is estimated to be 25%).
Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Mitchell MC, Boitnott JK, Arregui A, Maddrey WC. (1981). Granulomatous hepatitis associated with carbamazepine therapy. Am J Med. (Two men, ages 52 and 54 years, developed dark urine 3 weeks after starting carbamazepine, both with fever but no rash or eosinophilia [bilirubin 1.5 and 3.4 mg/dL, ALT 61 and 145 U/L, Alk P 80 and 236 U/L], biopsies showed granulomatous inflammation; both recovered within 4 weeks).
Levy M, Goodman MW, Van Dyne BJ, Sumner HW. (1981). Granulomatous hepatitis secondary to carbamazepine. Ann Intern Med. (Three patients developed fever, fatigue and abdominal pain 3-4 weeks after starting carbamazepine [bilirubin normal to 3.2 mg/dL, AST 20, 95 and 38 U/L, Alk P 1.5-2x ULN, no eosinophilia], biopsies showed granulomas; rechallenge in one led to immediate appearance of fever and rash; rapid recovery).
Hopen G, Nesthus I, Laerum OD. (1981). Fatal carbamazepine-associated hepatitis. Report of two cases. Acta Med Scand. (Two women, ages 23 and 37 years, developed rash and fever followed by jaundice 8 days after starting carbamazepine [peak bilirubin 7.9 and 14.0 mg/dL GGT 5350 and 205 U/L, ALT unknown and 1325 U/L], both had progressive liver failure and died; autopsies showed massive necrosis).
Yeung Laiwah AA, Rapeport WG, Thompson GG, et al. (1983). Carbamazepine-induced non-hereditary acute porphyria. Lancet. (Two patients on high doses of carbamazepine had decreased uroporphyrinogen I synthase [URO-S] and elevated δ aminolevulinic acid levels, and 1 developed symptoms of acute intermittent porphyria; cohort of patients on carbamazepine had slightly reduced levels of URO-S).
Perucca E, Hedges A, Makki KA, Ruprah M, Wilson JF, Richens A. (1984). A comparative study on the relative enzyme inducing properties of anticonvulsant drugs in epileptic patients. Br J Clin Pharmacol. (Cross sectional study of antipyrine clearance in 122 patients with epilepsy, found dose dependent increase in clearance in those on phenytoin, phenobarbital and carbamazepine, but not on valproate).
Davion T, Capron-Chivrac D, Andrejak M, Capron JP. (1985). Gastroenterol Clin Biol. (Review of 15 cases of carbamazepine hepatotoxicity in the literature; onset in 3-4 weeks in most cases, but occasionally longer; granulomatous hepatitis in 8 of 14 cases with biopsy, these cases being invariably benign; three reports of acute liver failure).
Larrey D, Hadengue A, Pessayre D, Choudat L, Degott C, Benhamou J-P. (1987). Carbamazepine-induced acute cholangitis. Dig Dis Sci. (79 year old woman developed itching 4 weeks and fever and jaundice [no rash] 7 weeks after starting clonazepam and carbamazepine [bilirubin 6.6 mg/dL, ALT 91 U/L, Alk P 5 times ULN, 54% eosinophils], liver biopsy showed cholestasis and “cholangitis”, resolving within 3 months of stopping carbamazepine, clonazepam being restarted).
Reinikainen KJ, Keranen T, Halonen T, Komulainen H, Riekkinen PJ. (1987). Comparison of oxcarbazepine and carbamazepine: a double-blind study. Epilepsy Research. (Among 18 patients on carbamazepine and 16 on oxcarbazepine, 2 developed transient ALT and AST elevations neither requiring dose adjustment).
Pellock JM. (1987). Carbamazepine side effects in children and adults. Epilepsia. (Analysis of side effects among 220 children on carbamazepine; skin rash in 5% and elevated liver tests in 6% but none “were of clinical significance.” Reports to Ciba-Geigy from 1975-86 included 45 with hepatitis and [5-10%] of patients with liver enzyme elevations).
Shear NH, Spielberg SP. (1988). Anticonvulsant hypersensitivity syndrome: in vitro assessment of risk. J Clin Invest. (PBMC cytotoxicity in response to drug metabolites from 53 patients with hypersensitivity to anticonvulsants including 35/36 to phenytoin, 22/27 to phenobarbital, and 25/27 to carbamazepine; 51% had hepatitis).
Robbie MJ, Scurry JP, Stevenson P. (1988). Carbamazepine-induced severe systemic hypersensitivity reaction with eosinophilia. Drug Intell Clin Pharm. (35 year old woman developed rash 3 weeks after starting carbamazepine, followed by fever and dyspnea with eosinophilia, respiratory and renal failure, responding to prednisone but then relapsing, developing jaundice late [bilirubin 8.8 mg/dL, AST 120 U/L, Alk P 2220 U/L], death from multiorgan failure 12 weeks later).
Aldenhövel HG. (1988). The influence of long-term anticonvulsant therapy with diphenylhydantoin and carbamazepine on serum gamma-glutamyltransferase, aspartate aminotransferase, alanine aminotransferase and alkaline phosphatase. Eur Arch Psychiatry Neurol Sci. (Among 54 patients on phenytoin and 56 on carbamazepine, elevations in GGT [14-283 U/L] were present in 91% and 64%, ALT [5-81 U/L] in 28% and 9%, and Alk P [71-216 U/L] in 39% vs 14%, most elevations were modest; GGT elevations were dose related, but not the others).
Dam M, Ekberg R, Løyning Y, Waltimo O, Jakobsen K. (1989). A double-blind study comparing oxcarbazepine and carbamazepine in patients with newly diagnosed, previously untreated epilepsy. Epilepsy Res. (Controlled trial of oxcarbazepine vs carbamazepine in 235 patients with epilepsy found similar therapeutic effect but lower rate of side effects with oxcarbazepine; liver tests fluctuated during therapy but only one patient [on carbamazepine] required drug discontinuation because of liver injury).
Durelli L, Massazza U, Cavallo R. (1989). Carbamazepine toxicity and poisoning. Incidence, clinical features and management. Med Toxicol Adverse Drug Exp. (Review of pharmacology and toxicity of carbamazepine; symptoms of overdose are largely neurological).
Askmark H, Wiholm B. (1990). Epidemiology of adverse reactions to carbamazepine as seen in a spontaneous reporting system. Acta Neurol Scand. (Analysis of 505 reports of adverse reaction to carbamazepine during 92 million dose-days from 1965-1987 in Sweden; 71 were liver related [16/100,000 treatment years], 21 with isolated ALT elevation after 4-46 days, 18 with ALT and Alk P elevations [after 16-60 days], and 25 with jaundice after 6 days to 2 years).
Frey B, Schubiger G, Musy JP. (1990). Transient cholestatic hepatitis in a neonate associated with carbamazepine exposure during pregnancy and breast-feeding. Eur J Pediatr. (Persistent jaundice at 3 weeks in male infant being breastfed by mother on carbamazepine [direct/total bilirubin 2.4/13.0 mg/dL, ALT 31 U/L, Alk P 402 U/L], liver biopsy showed cholestatic hepatitis, with rapid recovery on stopping).
Merlob P, Mor N, Litwin A. (1992). Transient hepatic dysfunction in an infant of an epileptic mother treated with carbamazepine during pregnancy and breastfeeding. Ann Pharmacother. (Newborn girl being breast fed by a mother taking carbamazepine had persisting jaundice in first 2 weeks of life [direct/total bilirubin 1.4/3.4 mg/dL, ALT 32 U/L, Alk P 293 U/L on day 5], resolving rapidly with stopping breastfeeding).
Forbes GM, Jeffrey GP, Shilkin KB, Reed WD. (1992). Carbamazepine hepatotoxicity: another cause of the vanishing bile duct syndrome. Gastroenterology. (59 year old man developed fever, rash and jaundice 2 months after starting carbamazepine [bilirubin 12.4 mg/dL, AST 99 U/L, Alk P 1030 U/L], evolving into chronic cholestasis and vanishing bile duct syndrome, which improved clinically, but liver tests were still abnormal 1 year later).
Friis ML, Kristensen O, Boas J, et al. (1993). Therapeutic experiences with 947 epileptic out-patients in oxcarbazepine treatment. Acta Neurol Scand. (Retrospective study of 947 patients treated with oxcarbazepine in 8 centers from 1981-90: adverse events in 33%, rash in 6%, elevations in laboratory results [ALT, AST, GGT or WBC] in <2%).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine but none reported in children on tiagabine or gabapentin).
Nathan DL, Belsito DV. (1998). Carbamazepine-induced pseudolymphoma with CD-30 positive cells. J Am Acad Dermatol. (44 year old woman with a history of phenytoin sensitivity developed fever, lymphadenopathy, pneumonitis, and rash one month after starting carbamazepine [bilirubin not given, AST 282 U/L, Alk P 44 U/L] and atypical CD-30 T cells in blood, resolution in 3 weeks on stopping).
Schlienger RG, Shear NH. (1998). Antiepileptic drug hypersensitivity syndrome. Epilepsia. (Review of the clinical features of anticonvulsant hypersensitivity syndrome).
Hamer HM, Morris HH. (1999). Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Cleve Clin J Med. (Clinical review of anticonvulsant hypersensitivity syndrome, which occurs in 1-5 per 10,000 users, higher risk in African Americans and affected siblings; liver involvement common, but most cases anicteric; other manifestations include facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, interstitial nephritis).
Knowles SR, Shapiro LE, Shear NH. (1999). Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf. (Review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant; liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to acute liver failure. High mortality rate with jaundice; other organs include muscle, kidney, brain, heart and lung. Pseudolymphoma syndrome and serum sickness like syndrome are separate complications of anticonvulsants. Role of corticosteroids uncertain; cross reactivity among the agents should be assumed).
Hamer HM, Morris HH. (1999). Successful treatment with gabapentin in the presence of hypersensitivity syndrome to phenytoin and carbamazepine: a report of three cases. Seizure. (3 patients developed rash, fever, lymphadenopathy and eosinophilia 4-6 weeks after starting either phenytoin or carbamazepine [bilirubin 0.5-1.8 mg/dL, ALT 866-1402 U/L, Alk P 69-364 U/L], resolving after stopping and not recurring during gabapentin therapy).
Descamps V, Valance A, Edlinger C, Fillet AM, Grossin M, Lebrun-Vignes B, Belaich S, et al. (2001). Association of human herpesvirus 6 infection with drug reaction with eosinophilia and systemic symptoms. Arch Dermatol. (Among 7 patients with DRESS syndrome, all had anti-HHV-6, 2 in rising titers, 4 with IgM, none had HHV-6 DNA; 5 cases due to carbamazepine, 1 sulfasalazine and 1 ibuprofen).
Sullivan JR, Shear NH. (2001). The drug hypersensitivity syndrome. What is the pathogenesis?. Arch Dermatol. (Review of clinical features, major causes and suspected pathogenesis of DRESS; major causes are aromatic anticonvulsants, abacavir, azathioprine, and sulfonamides).
Garcia M, Mhanna MJ, Chung-Park MJ, Davis PH, Srivastava MD. (2002). Efficacy of early immunosuppressive therapy in a child with carbamazepine-associated vanishing bile duct and Stevens-Johnson syndromes. Dig Dis Sci. (4 year old developed necrotizing rash and fever 4 months after starting carbamazepine [bilirubin 4.0 mg/dL, ALT 673 U/L, Alk P 481 U/L, GGT 613 U/L], Stevens-Johnson syndrome; biopsy showing “early” vanishing bile duct syndrome, treated with corticosteroids with rapid response but slow decline in GGT and cholesterol at the time of 6 week follow up).
Frey B, Braegger CP, Ghelfi D. (2002). Neonatal cholestatic hepatitis from carbamazepine exposure during pregnancy and breast feeding. Ann Pharmacother. (Newborn boy developed jaundice and mild elevations in GGT, Alk P and ALT 3 to 4 weeks after difficult birth to mother on carbamazepine who breastfed: two previous cases discussed).
Bosdure E, Cano A, Roquelaure B, Reynaud R, Boyer M, Viard L, Sarles J. (2004). Arch Pediatr. (11 year old girl developed rash, fever and eosinophilia 43 days after starting oxcarbazepine [bilirubin not given, ALT 25 times ULN, Alk P not given, factor V 15%], progressing to hepatic failure, but eventually improving spontaneously and resolving completely within 6 weeks).
Tohyama M, Hashimoto K, Yasukawa M, Kimura H, Horikawa T, Nakajima K, Urano Y, et al. (2007). Association of human herpesvirus 6 reactivation with the flaring and severity of drug-induced hypersensitivity syndrome. Br J Dermatol. (Anti-HHV-6 testing of 100 patients with drug induced hypersensitivity syndrome [34% with hepatitis] found rise in IgG levels in 62 patients, largely in more severe cases; HHV-6 DNA detected in 18; drugs included carbamazepine, phenobarbital, phenytoin, allopurinol, sulfasalazine and mexiletine).
Ganeva M, Gancheva T, Lazarova R, Troeva J, Balarenov I, Vassilev I, Hristakieva E, et al. (2008). Carbamazepine-induced drug reaction with eosinophilia and systemic symptoms(DRESS) syndrome: report of four cases and brief review. Int J Dermatol. (Review of carbamazepine induced hypersensitivity syndromes and 4 case reports; onset after 3-4 weeks of starting carbamazepine with rash, fever and eosinophilia, 2 with liver involvement and 1 with jaundice, all treated with corticosteroids and all resolved without recurrence, 3 taking valproate).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, valproate accounted for 6, lamotrigine 5, phenytoin 5, gabapentin and topiramate 1 each; none were due to oxcarbazepine).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of all anticonvulsants including 60 cases of carbamazepine usually part of hypersensitivity syndrome, typically mixed enzyme pattern, 27% with eosinophilia, mean onset at 5 weeks, 17% mortality more common in children, with hepatocellular pattern of enzymes and with longer latency to onset; mentions oxcarbazepine has been linked to a few cases reports showing mild-to-moderate liver test elevations).
Franzoni E, Gentile V, Pellicciari A, Garone C, Iero L, Gualandi S, Cordelli DM, et al. (2009). Prospective study on long-term treatment with oxcarbazepine in pediatric epilepsy. J Neurol. (Among 36 children with epilepsy treated with oxcarbazepine for up to 3 years, “no hepatic dysfunctions were reported”).
Buggy Y, Layton D, Fogg C, Shakir SA. (2010). Safety profile of oxcarbazepine: results from a prescription-event monitoring study. Epilepsia. (Results of mail survey of 2243 patients given a prescription for oxcarbazepine by physicians in England between 2000 and 2003, mostly for seizures but also trigeminal neuralgia and neuropathic pain; 40% as monotherapy, most common side effects were sedation, nausea, malaise and dizziness; no mention of liver injury or ALT elevations).
Hsu HF, Huang SY. (2010). Severe hepatitis associated with administration of oxcarbazepine. Pediatr Int. (8 year old girl with partial seizures developed malaise, fever and pharyngitis without rash 12 days after starting oxcarbazepine [bilirubin 0.6 mg/dL, ALT 1258 U/L, Alk P 128 U/L], resolving rapidly upon stopping and then tolerating levetiracetam).
(2013). Drugs for epilepsy. Treat Guidel Med Lett. (Concise review of drugs of choice for epilepsy; oxcarbazepine alone or in combination is useful for treatment of partial seizures; adverse events include somnolence, dizziness, diplopia, ataxia, nausea and vomiting; liver injury is not mentioned).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 1 attributed to phenytoin among only 410 persons receiving the drug in Iceland; no case was attributed to oxcarbazepine).
Planjar-Prvan M, Bielen A, Sruk A, Marusić M, Bielen I. (2013). Acute oxcarbazepine-induced hepatotoxicity in a patient susceptible to developing drug-induced liver injury. Coll Antropol. (23 year old woman developed fatigue, anorexia, and abnormal liver tests without fever or rash 3 weeks after starting oxcarbazepine [bilirubin normal, peak ALT 17 times ULN, Alk P 2.2 times ULN], falling into the normal range 4 months after switching to gabapentin; two years later she developed abnormal enzymes during therapy with amoxicillin/clavulanate).
Kaniwa N, Saito Y. (2013). The risk of cutaneous adverse reactions among patients with the HLA-A* 31:01 allele who are given carbamazepine, oxcarbazepine or eslicarbazepine: a perspective review. Ther Adv Drug Saf. (Review of HLA-A*31:01 and cutaneous reactions to carbamazepine found a significant association with the spectrum of cutaneous reactions [maculopapular, erythema multiforme, SJS and TEN] in both Asian and European populations, unlike HLA-B*15:02 which is closely linked to SJS/TEN but largely among Han Chinese populations; associations of A*31:01 with oxcarbazepine have not been made and links of cutaneous reactions with B*15:02 appear to be weaker than with carbamazepine).
French JA, Baroldi P, Brittain ST, Johnson JK, PROSPER Investigators Study Group. (2014). Efficacy and safety of extended-release oxcarbazepine (Oxtellar XR™) as adjunctive therapy in patients with refractory partial-onset seizures: a randomized controlled trial. Acta Neurol Scand. (Among 366 patients with partial onset seizures treated with adjunctive extended release oxcarbazepine [1200 or 2400 mg] or placebo for 16 weeks, seizure frequency decreased with the higher dose of oxcarbazepine, while adverse events were also more frequent particularly dizziness, asthenia and fatigue; no mention of ALT elevations or hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 7 [4%] of which were attributed to anticonvulsants including 3 due to phenytoin, 3 to valproate and 1 to carbamazepine; none were attributed to oxcarbazepine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were due to anticonvulsants including 12 due to phenytoin, 9 lamotrigine, 7 valproate, 4 carbamazepine, 3 gabapentin, 2 topiramate and 1 each for ethosuximide, fosphenytoin, and pregabalin; none were attributed to oxcarbazepine).
Chung SS, Johnson JK, Brittain ST, Baroldi P. (2016). Long-term efficacy and safety of adjunctive extended-release oxcarbazepine (Oxtellar XR®) in adults with partial-onset seizures. Acta Neurol Scand. (Among 214 patients with refractory partial onset seizures participating in a controlled trial [French 2014] who were then treated with open label oxcarbazepine [1200 mg] for 48 weeks, adverse events included dizziness, headache, diplopia, nausea and asthenia and led to early discontinuation in 5% of patients; no mention of ALT elevations or cutaneous reactions).
Trivedi BS, Darji NH, Malhotra SD, Patel PR. (2016). Antiepileptic drugs-induced Stevens-Johnson syndrome: a case series. J Basic Clin Pharm. (Among 9 cases of Stevens-Johnson syndrome seen at a large referral center in India, 5 were due to phenytoin, 2 carbamazepine and 2 oxcarbazepine: 18 year old female and 58 year old man who developed rash within 4 and 7 days of starting oxcarbazepine, both had rapid improvement on stopping; no mention of hepatic involvement).
Chait Mermelstein A, Mermelstein J, Adam T, Brody BD, Dubin MJ. (2016). Oxcarbazepine-induced liver injury after sensitization by valproic acid: a case report. Bipolar Disord. (46 year old woman with bipolar disorder treated with valproate for 3 years was found to have liver enzyme elevations [ALT 163 U/L, Alk P 180 UL, bilirubin normal], which improved on stopping valproate but ALT rose again when she was started on oxcarbazepine which resolved on stopping and recurred on restarting).
Yip VL, Pirmohamed M. (2017). The HLA-A*31:01 allele: influence on carbamazepine treatment. Pharmgenomics Pers Med. (Review of HLA-A*31:01 and risk of cutaneous adverse events due to carbamazepine mentions that the spectrum of associations is wider than with HLA-B*15:02 and is a risk factor in both Asian and European populations; in contrast there is little evidence of linkage of A*31:01 or B*15:02 with oxcarbazepine cutaneous reactions, although few cases have been studied).
Kim JH, Lee SK, Loesch C, Namgoong K, Lee HW, Hong SB. (2017). Korean N01367 Study Group. Comparison of levetiracetam and oxcarbazepine monotherapy among Korean patients with newly diagnosed focal epilepsy: A long-term, randomized, open-label trial. Epilepsia. (Among 347 adults with new onset focal epilepsy treated with levetiracetam or oxcarbazepine for 48 weeks, seizure free rates were similar in the 2 groups as were adverse event rates; no mention of severe cutaneous reactions or hepatotoxicity).
Vidaurre J, Gedela S, Yarosz S. (2017). Antiepileptic drugs and liver disease. Pediatr Neurol. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, levetiracetam being an "ideal" first line therapy for patients with liver disease because of its safety and lack of pharmacokinetic interactions).
(2017). Drugs for epilepsy. Med Lett Drugs Ther. (Concise review of the drugs available for therapy of epilepsy list oxcarbazepine as similar chemically to carbamazepine, but as being better tolerated and with fewer drug-drug interactions and lower rates of serious adverse events including Stevens-Johnson syndrome and toxic epidermal necrolysis; no mention of ALT elevations or hepatotoxicity).
Borrelli EP, Lee EY, Descoteaux AM, Kogut SJ, Caffrey AR. (2018). Stevens-Johnson syndrome and toxic epidermal necrolysis with antiepileptic drugs: An analysis of the US Food and Drug Administration Adverse Event Reporting System. Epilepsia. (Review of adverse event reports to the FDA between 2014 and 2018 identified ~2.9 million reports, 1034 for SJS/TEN, the most common class of drugs being anticonvulsants with 17 of 34 currently available anticonvulsants having at least one report, those most frequently linked being lamotrigine [n=106], carbamazepine [22], levetiracetam [14], phenytoin [14], valproate [9], clonazepam [8], zonisamide [7]; pregabalin [4], gabapentin [4] and oxcarbazepine [3]; no mention of accompanying liver injury or whether attribution was as a single agent or one of several).
Tangamornsuksan W, Scholfield N, Lohitnavy M. (2018). Association between HLA genotypes and oxcarbazepine-induced cutaneous adverse drug reactions: a systematic review and meta-analysis. J Pharm Pharm Sci. (Metaanalysis of six studies of HLA associations with oxcarbazepine induced cutaneous reactions identified 229 cases, 251 drug-tolerant controls and 2358 population controls [Asians] with a significant association of SJS/TEN with HLA-B*15:02 and of maculopapular rash with HLA-A*31:01:).
Han XD, Koh MJ, Wong SMY. (2019). Drug reaction with eosinophilia and systemic symptoms in a cohort of Asian children. Pediatr Dermatol. (Among 10 children with DRESS syndrome seen at a single, Singapore referral center between 2006 and 2016, 3 cases were attributed to SMZ/TMP, 2 to carbamazepine, 1 sulfasalazine, 2 phenobarbital and 1 levetiracetam, but none to oxcarbazepine; all had ALT elevations [88 to 1172 U/L], bilirubin was elevated in 7, but none had acute liver failure and none were fatal).
Cano-Paniagua A, Amariles P, Angulo N, Restrepo-Garay M. (2019). Epidemiology of drug-induced liver injury in a University Hospital from Colombia: Updated RUCAM being used for prospective causality assessment. Ann Hepatol. (Among 286 patients with liver test abnormalities seen in a single hospital in Colombia over a 1 year period, 17 were diagnosed with drug induced liver injury, the most common cause being antituberculosis therapy [n=6] followed by anticonvulsants [n=3, 1 each due to phenytoin, gabapentin and valproate]).
Wang YH, Chen CB, Tassaneeyakul W, Saito Y, Aihara M, Choon SE, Lee HY, et al., Asian Severe Cutaneous Adverse Reaction Consortium. (2019). The medication risk of Stevens-Johnson Syndrome and toxic epidermal necrolysis in Asians: the major drug causality and comparison with the US FDA label. Clin Pharmacol Ther. (Among 1028 cases of SJS/TEN reported to registries in 8 Asian countries, the most frequently implicated class of drugs was anticonvulsants including carbamazepine [26%], phenytoin [13%], lamotrigine [10%], phenobarbital [2%] and oxcarbazepine [1.7%]; non-anticonvulsant causes included allopurinol [20%] and sulfamethoxazole [8%]).
Kim HK, Kim DY, Bae EK, Kim DW. (2020). Adverse skin reactions with antiepileptic drugs using Korea adverse event reporting system database, 2008-2017. J Korean Med Sci. (Among 2942 reports of cutaneous drug reactions made to a Korean pharmacovigilance registry between 2008 and 2017, 241 [8%] were for severe cutaneous reactions [DRESS in 109, SJS in 106 and TEN in 25] the most common causes of which were carbamazepine [24%], lamotrigine [24%], valproate [8%], phenytoin [6%] and oxcarbazepine [5%]; no mention of accompanying ALT elevations or hepatotoxicity ).
Li R, Zhou Q, Ou S, Wang Y, Li Y, Xia L, Pan S. (2020). Comparison of long-term efficacy, tolerability, and safety of oxcarbazepine, lamotrigine, and levetiracetam in patients with newly diagnosed focal epilepsy: an observational study in the real world. Epilepsy Res. (Among 388 patients with new onset focal epilepsy, seizure free rates at three years were lower for oxcarbazepine [26%], than lamotrigine [40%] or levetiracetam [40%], while adverse events leading to discontinuation were higher 9% vs 9% vs 2%], 14% of discontinuations were attributed to abnormal liver tests; no mention of clinically apparent hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Oxcarbazepine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(oxcarbazepine+AND+Carbamazepine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Oxcarbazepine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=oxcarbazepine)